# Procarbazine

## OVERVIEW

### Introduction

Procarbazine is an orally administered alkylating agent used in combination with other antineoplastic agents in the therapy of Hodgkin’s disease and malignant melanoma. Procarbazine therapy has been associated with serum enzyme elevations during therapy and with rare cases of idiosyncratic, clinically apparent acute liver injury.

### Background

Procarbazine (proe kar' ba zeen) is a methylhydrazine derivative which is activated in the liver to highly reactive alkylating intermediates. These intermediates methylate DNA which causes inhibition of DNA, RNA and protein synthesis and cell death. Procarbazine was approved for use in the United States in 1969 and it remains a commonly used agent in the treatment of Hodgkin’s and non-Hodgkin’s lymphomas and brain cancer. Procarbazine is rarely used alone, but is found in common cancer chemotherapeutic regimens such as MOPP (mechlorethamine, vincristine [oncovin], procarbazine and prednisone), COPP (cyclophosphamide, vincristine [oncovin], procarbazine and prednisone), and PCV (procarbazine, lomustine [CCNU], vincristine). Procarbazine is available as tablets of 50 mg generically and under the brand name Matulane. It is typically given in monthly or every other month cycles of 10 to 14 days in a dose of 100 mg per meter squared body surface area. Common side effects are alopecia, anoxia, nausea, vomiting, headache, peripheral neuropathy, and flu-like illness. Severe adverse events include myelosuppression, neurologic and renal dysfunction.

### Hepatotoxicity

Mild and transient elevations in serum aminotransferase levels are not uncommon during courses of systemic combination chemotherapy and the role of procarbazine in these abnormalities is often not clear. Aminotransferase elevations arise in more than half of patients and rise above 5 times ULN in 10 to 20% of patients. However, dose modification for serum enzyme elevations is rarely necessary. Clinically apparent liver disease with fever and marked elevations in serum aminotransferase levels without jaundice has been reported but is very rare. A single case report described self-limited, hepatocellular injury without jaundice during a second course of combination therapy and recurrence upon rechallenge with procarbazine, but not with the other antineoplastic agents being used.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of hepatotoxicity from procarbazine is not known, but may be due to hypersensitivity.

### Outcome and Management

The severity of liver injury from procarbazine is usually mild and self-limiting. Procarbazine therapy has not been associated with cases of acute liver failure, chronic liver injury or vanishing bile duct syndrome. The product label for procarbazine recommends obtaining routine liver and kidney tests before starting and every week during therapy. Elevations of aminotransferase levels above 5 times ULN should be managed by temporary discontinuation of procarbazine until the abnormalities resolve.

Drug Class: Antineoplastic Agents, Alkylating Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Procarbazine – Matulane®

DRUG CLASS

Antineoplastic Agents, Alkylating Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Procarbazine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Procarbazine | 671-16-9 | C12-H19-N3-O

## ANNOTATED BIBLIOGRAPHY

References updated: 12 September 2020

Zimmerman HJ. Oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity of cancer chemotherapeutic agents published in 1999; mentions that procarbazine appears to produce little hepatic injury, and its other side effects outweigh the importance of its hepatotoxicity).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 549-68. (Review of hepatotoxicity of cancer chemotherapeutic agents does not discuss procarbazine).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Cytotoxic agents. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1167-201. (Textbook of pharmacology and therapeutics).
Jones RJ, Lee KS, Beschorner WE, Vogel VG, Grochow LB, Braine HG, Vogelsang GB, et al. (1987). Veno-occlusive disease of the liver following bone marrow transplantation. Transplantation. (Among 235 patients undergoing bone marrow transplantation between 1982 and 1985, sinusoidal obstruction syndrome [SOS] developed in 52 [22%] of whom half died, making SOS the third most common cause of death in this population).
Fesler MJ, Becker-Koepke S, Di Bisceglie AM, Petruska PJ. (2010). Procarbazine-induced hepatotoxicity: case report and review of the literature. Pharmacotherapy. (65 year old man with lymphoma developed fever and transient marked elevations in ALT [~2100 U/L] and LDH [873 U/L] during second course of C-MOPP-R and had a positive rechallenge to procarbazine [fever and ALT elevations to ~800 U/L], but no recurrence with other components of the treatment regimen).
Hallén K, Sangfelt P, Nilsson T, Nordgren H, Wanders A, Molin D. (2014). Vanishing bile duct-like syndrome in a patient with Hodgkin lymphoma – pathological development and restitution. Acta Oncol. (Man of unstated age developed jaundice and severe pruritus with vanishing bile duct syndrome due to Hodgkin disease [bilirubin 5.5 rising to 34 mg/dL], eventually responding after courses of procarbazine containing combination chemotherapies and having normal liver tests in long term follow up).
Thakar K, Novero A, Das A, Lisinschi A, Mehta B, Ahmed T, Liu D. (2014). CEPP regimen (cyclophosphamide, etoposide, procarbazine and prednisone) as initial treatment for Hodgkin lymphoma patients presenting with severe abnormal liver function. Biomark Res. (Two patients with Hodgkin disease presented with jaundice and responded to chemotherapy with cyclophosphamide, etoposide, procarbazine and prednisone with improvement in the liver disease allowing for more aggressive chemotherapy).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 363 [36%] were attributed to antibiotics, none of which was attributed to procarbazine).
Jutras G, Bélanger K, Letarte N, Adam JP, Roberge D, Lemieux B, Lemieux-Blanchard É, et al. (2018). Procarbazine, lomustine and vincristine toxicity in low-grade gliomas. Curr Oncol. (Among 57 patients with low grade gliomas treated with procarbazine, lomustine and vincristine at a single center between 2005 and 2015, hematologic, hepatologic and other toxicities were common, ALT elevations occurring in 65% and rising to above 5 times ULN in 18% of patients, usually attributed to and leading to discontinuation of procarbazine, but not resulting in any toxic deaths).
Fong M, Boyle S, Gutta N. (2019). Brentuximab vedotin in combination with sequential procarbazine, cyclophosphamide and prednisolone for the management of Hodgkin's lymphoma-associated vanishing bile duct syndrome (VBDS) with severe obstructive liver failure. BMJ Case Rep. (39 year old woman with jaundice, severe itching and vanishing bile duct syndrome due to Hodgkin disease [bilirubin 9.9 rising to 23.6 mg/dL, ALT 8 times and Alk P 5 times ULN] responded to therapy with cyclophosphamide, procarbazine and prednisone [bilirubin 0.8 mg/dL], allowing for more aggressive therapy).

## OTHER REFERENCE LINKS

1 Recent References on Procarbazine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Procarbazine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Procarbazine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Procarbazine)